# Chlorpromazine

## OVERVIEW

### Introduction

Chlorpromazine is a phenothiazine that was once the most commonly prescribed antipsychotic agent, but that is now rarely used. Chlorpromazine can cause mild and transient serum enzyme elevations and is also a well known cause of clinically apparent acute and chronic cholestatic liver injury.

### Background

Chlorpromazine (klor proe' ma zeen) is a tricyclic aliphatic phenothiazine which acts by postsynaptic inhibition of dopamine receptors. Chlorpromazine has other peripheral and central nervous system effects, producing both alpha adrenergic stimulation and blocking histamine- and serotonin-mediated effects. Chlorpromazine is indicated for the therapy of acute and chronic psychosis and for nausea and intractable hiccups. Chlorpromazine was approved for use in the United States in 1957 and was formerly the most commonly prescribed antipsychotic medication, being the prototypic, standard neuroleptic agent against which other antipsychotic agents were tested. In recent years, chlorpromazine has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal and hepatic side effects. Current indications include psychotic disorders, schizophrenia, nausea and vomiting, acute intermittent porphyria and intractable hiccups. Chlorpromazine is available in multiple generic forms as tablets of 10, 25, 50, 100 and 200 mg, as extended release capsules of 200 and 300 mg, and as syrup in various concentrations. Parenteral forms are also available. Chlorpromazine was formerly available under the brand names Thorazine and Largactil. The typical maintenance dose of chlorpromazine is 100 to 200 mg daily. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, constipation, tremor, restlessness, muscle spasms and weight gain.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 40% of patients on long term therapy with chlorpromazine, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually self-limited and unaccompanied by symptoms, reversing even without discontinuation.

Chlorpromazine is also a well known cause of acute cholestatic liver injury. Numerous instances of clinically apparent acute liver injury due to chlorpromazine have been reported in the literature, which is estimated to occur in 1:500 persons exposed. Chlorpromazine was formerly the most common cause of drug induced liver injury in the United States, but with the decrease in its use, chlorpromazine associated jaundice is now rarely reported. The clinical presentation and course are well defined. The onset of jaundice is usually within 1 to 5 weeks, and the pattern of serum enzyme elevations is typically cholestatic or mixed (Case 1). Immunoallergic manifestations (fever, rash and eosinophilia) occur in some but not all cases, and these manifestations are usually mild and self-limited. Autoantibody formation is rare. Most importantly, chlorpromazine jaundice can be prolonged and associated with vanishing bile duct syndrome (Case 2).

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which chlorpromazine causes serum aminotransferase elevations is not known. The clinically apparent liver injury due to chlorpromazine is likely due to hypersensitivity, based upon the clinical features of a short latency period, fever, eosinophilia, and rapid recurrence upon reexposure. Chlorpromazine is extensively metabolized by the liver via sulfoxidation and oxidation, and some instances of serum aminotransferase elevations as well as more clinically apparent liver injury may be caused by production of a toxic intermediate of its metabolism. Chlorpromazine therapy can also cause weight gain, and some instances of liver test abnormalities during therapy may due to nonalcoholic fatty liver disease.

### Outcome and Management

The serum aminotransferase elevations that occur on chlorpromazine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute cholestatic hepatitis caused by chlorpromazine is typically self-limited and benign, but should prompt immediate discontinuation. Up to 7% of cases of chlorpromazine induced cholestasis are followed by prolonged jaundice, and several instances of vanishing bile duct syndrome have been attributed to chlorpromazine. Many patients with chronic cholestasis eventually improve, but they often have persistent enzyme elevations and may develop biliary cirrhosis. Fatalities from chlorpromazine jaundice have been reported. Rechallenge with chlorpromazine usually causes a prompt recurrence of the liver injury and should be avoided. Patients with chlorpromazine induced liver injury may have cross sensitivity to other phenothiazines, but generally tolerate the atypical antipsychotics. Patients with symptomatic cholestasis may benefit from ursodiol therapy (12-15 mg/kg/day). Ursodiol is generally safe and well tolerated, but it has not been rigorously evaluated for efficacy in controlled trials in drug induced liver injury. Corticosteroids are often used in patients with severe cholestatic injury due to medications, particularly if there are accompanying signs of hypersensitivity, but their efficacy has never been shown and they rarely appear to have an effect on cholestasis.

Drug Class: Gastrointestinal Agents; Antipsychotic Agents

Other Drugs in the Subclass, Antipsychotic Agents, Phenothiazines: Fluphenazine, Perphenazine, Prochlorperazine, Thioridazine, Trifluoperazine

## CASE REPORTS

### Case 1. Acute cholestatic hepatitis due to chlorpromazine.

[Modified from: Werther JL, Korelitz BI. Chlorpromazine jaundice: analysis of twenty-two cases. Am J Med 1957; 22: 351-66. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/13402787)] [Case 4]

A 26 year old woman with depression was started on chlorpromazine (75 mg/day) and developed generalized pruritus one week later followed by fever, nausea and dark urine. After 21 days of therapy, she was seen by her physician and chlorpromazine was stopped. There was no history of liver disease or alcohol abuse. She was jaundiced but afebrile and without rash. The liver was enlarged but nontender. Serum bilirubin was 12.4 mg/dL and alkaline phosphatase 36.3 King-Armstrong units (normal <13) (Table). A total white blood cell count was normal and eosinophils were 4% (~330/µL). An oral cholecystogram was normal. A liver biopsy showed intrahepatic cholestasis and portal infiltrates populated by eosinophils. Over the next few weeks she began to improve and laboratory test results returned to normal within 10 weeks.

#### Key Points

Medication: | Chlorpromazine (75 mg/day)
Pattern: | Cholestatic
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1-2 weeks
Recovery: | 6 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | Alk P (K-A U/L) | Bilirubin (mg/dL) | Other
Pre | | Chlorpromazine (75 mg/day) given for 21 days
3 weeks | 4 days | 36.3 | 12.4 | Eosinophils 4%
4 weeks | 11 days | 25.6 | 9.1 | Eosinophils 6%
5 weeks | 18 days | 30.4 | 6.1
6 weeks | 25 days | 19.4 | 3.8
13 weeks | 10 weeks | 7.7 | 0.7
Normal Values | | <13 | <1.2

* Some values estimated from Figure 1 and bilirubin converted from μmol/L to mg/dL.

#### Comment

The typical cholestatic hepatitis caused by chlorpromazine (“Thorazine jaundice”) is marked by short incubation period (1-4 weeks), jaundice and pruritus (the itching can arise even before jaundice) and a benign, self-limited course. This case was published before general availability of serum aminotransferase measurements, and long before availability of commercial assays for hepatitis A (1982), B (1972) and C (1992). Chlorpromazine used to be the most common cause of drug induced liver injury in the United States and many western countries. Now, chlorpromazine is rarely used, and it no longer even appears in the lists of drugs implicated in case series of drug induced liver injury. Most of the other phenothiazines used in treatment of psychosis have also been implicated in cases of cholestatic jaundice with a similar clinical course, but at a lower frequency than with chlorpromazine.

### Case 2. Acute cholestatic hepatitis evolving into chronic cholestatic syndrome with paucity of bile ducts and biliary fibrosis.

[Modified from: Moradpour D, Altorfer J, Flury R, Greminger P, Meyenberger C, Jost R, Schmid M. Chlorpromazine-induced vanishing bile duct syndrome leading to biliary cirrhosis. Hepatology 1994; 20: 1437-41. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7982642)]

A 34 year old pregnant woman was treated with chlorpromazine (25 mg twice daily) for hyperemesis gravidarum and developed fatigue and dark urine 2 weeks later followed by pruritus and jaundice. Chlorpromazine was stopped. Blood testing showed marked increases in serum bilirubin, ALT and alkaline phosphatase (Table). Tests for acute hepatitis A, B and C were negative as were autoantibodies including antinuclear, smooth muscle and mitochondrial antibodies. She had no previous history of liver disease, risk factors for viral hepatitis or alcohol abuse. She was approximately 2 months pregnant. She remained jaundiced throughout pregnancy that was terminated by Caesarian section at week 28. A concurrent liver biopsy showed severe intrahepatic cholestasis, portal inflammation and bile duct injury. After delivery of twin girls she remained jaundiced and had persistent and unrelenting pruritus. Various therapies including antihistamines, phenobarbital, cholestyramine, S-adenosylmethionine, prednisone, phototherapy and plasmapheresis were of minimal benefit. A repeat liver biopsy at 8 months after onset showed increased cholestasis and reduction in number of bile ducts, and a third liver biopsy after 14 months showed bridging fibrosis and paucity of bile ducts (ducts were detectable in only 3 of 16 portal tracts). She had enlargement of the liver and spleen, marked weight loss, steatorrhea, and symptoms of severe pruritus and fatigue. She was started on ursodiol (900 mg daily) and simultaneously began to improve clinically. Jaundice resolved 20 months after initial onset, after which serum alkaline phosphatase and ALT levels fell into the range of 1.5 to 3 fold elevated. Serum albumin and prothrombin time remained normal throughout the course. Ultrasound of the abdomen showed changes suggestive of cirrhosis and a fourth liver biopsy, 46 months after initial onset, showed biliary cirrhosis with minimal inflammation and focal areas of cholestasis and bile duct paucity (ducts detected in 5 of 12 portal tracts).

#### Key Points

Medication: | Chlorpromazine (50 mg daily for 20 days)
Pattern: | Cholestatic (R=~0.1 at peak)
Severity: | 4+ (prolonged jaundice, cirrhosis)
Latency: | 2 weeks
Recovery: | Incomplete after 4 years
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | Chlorpromazine (50 mg daily for 20 days) given for nausea
3 weeks | 0 | 60 | 100 | 7.0 | 2 Months pregnant
5 months | 4 months | 60 | 510 | 35.0 | Delivery: liver biopsy #1
| 6 months | 120 | 400 | 22.0
| 8 months | 184 | 4128 | 32.7 | Liver biopsy #2
| 10 months | 140 | 1800 | 19.0
| 12 months | 150 | 2100 | 22.9
| 14 months | 110 | 550 | 20.5 | Liver biopsy #3
| 4 years | 100 | 280 | 1.5 | Liver biopsy #4
Normal Values | | <42 | <90 | <1.2

* Some values estimated from Figure 4 and bilirubin converted from μmol/L to mg/dL.

#### Comment

A typical cholestatic hepatitis from chlorpromazine was followed by persistent cholestasis with jaundice and pruritus. Her pregnancy was terminated early because of the jaundice, with a Caesarian section during which a liver biopsy was done that showed severe cholestatic hepatitis with bile duct injury. Follow up liver biopsies at 8, 12 and 46 months after onset showed loss of bile ducts, but eventually a gradual improvement in cholestasis. Nevertheless, the patient developed cirrhosis and the long term prognosis remains uncertain. This is a dramatic and well documented example of vanishing bile duct syndrome developing after an acute cholestatic hepatitis due to chlorpromazine. Ursodiol therapy appeared to improve both symptoms and laboratory test results, but some degree of clinical improvement had started before therapy was initiated. Many instances of vanishing bile duct syndrome due to chlorpromazine have been published. Ursodiol is often used, but its efficacy in ameliorating or shortening the course of illness is not clear. It is appropriate to use, particularly if there is symptomatic improvement.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chlorpromazine – Generic, Largactil®, Thorazine®

DRUG CLASS

Gastrointestinal Agents; Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chlorpromazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chlorpromazine | 50-53-3 | C17-H19-Cl-N2-S | Chlorpromazine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 October 2017

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including chlorpromazine published in 1999 mentions that several hundred cases of chlorpromazine jaundice have been reported, usually cholestatic, arising after 1-5 weeks, often with fever and eosinophilia, sometimes causing vanishing bile duct syndrome; estimated to occur in 1% of exposed persons with minor enzyme elevations in a higher proportion).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 447-62. (Review of chlorpromazine hepatotoxicity mentions that liver enzyme elevations arise in up to 40% of patients, and hundreds of cases of chlorpromazine jaundice have been published, frequency ~0.5-1%; onset in 2-5 weeks, usually acute cholestatic hepatitis with jaundice and pruritus; prodrome of fever and abdominal pain is common; prolonged course in 7% but most commonly benign).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Chabner BA, Knollman BA, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 417-56. (Textbook of pharmacology and therapeutics).
Zatuchni J, Miller G. Jaundice during chlorpromazine therapy. N Engl J Med 1954; 251: 1003-6. (70 year old woman developed jaundice 2 weeks after starting chlorpromazine [bilirubin 13 mg/mL, Alk P ~5.5 times ULN], biopsy showing intrahepatic cholestasis, resolving 6 weeks after stopping). 13214378
Boardman RH. Fatal case of toxic hepatitis implicating chlorpromazine. BMJ 1954; 2: 579. (Among 500 patients receiving chlorpromazine, 6 developed jaundice and one died; 45 year old woman developed jaundice and fever after 3 weeks of therapy [bilirubin rising to 23 mg/dL, Alk P 3-4 times ULN], followed by stupor, coma and death; congestive heart failure also present). 13182288
Tasker JR. Fatal agranulocytosis during treatment with chlorpromazine. BMJ 1955; 1: 950-1. (38 year old woman developed weakness and fever 10 days after starting chlorpromazine, with rash and jaundice; chlorpromazine was continued and she developed mouth ulcers, anemia and neutropenia resulting in death from septicemia 6 weeks after starting drug). 14363757
Hartnett BS. Liver damage and eosinophilia following chlorpromazine therapy: report of a case. BMJ 1955; 1: 1458-9. (52 year old man developed nausea 10 days after starting chlorpromazine followed by with fever and jaundice [bilirubin 3.8 mg/dL, Alk P 1.5 times ULN, 49% eosinophilia], resolving slowly over several months after stopping). 14378593
Isaacs B, MacArthur JG, Taylor RM. Jaundice in relation to chlorpromazine therapy. BMJ 1955; 2; 1122-3. (Among 26 patients given chlorpromazine for 1 to 2 weeks for nausea, 4 developed jaundice between 4 and 14 days after starting; survey in Scotland found 39 of 3252 patients [1.2%] on chlorpromazine developed jaundice within 2-35 days, 1 fatality). 13260678
Van Ommen R, Brown C. Obstructive-type jaundice due to chlorpromazine(thorazine); report of three cases. JAMA 1955; 157: 321-5. (3 women, ages 36 to 64 years, with onset of jaundice 3-4 weeks after starting chlorpromazine [bilirubin 2.5-4.4 mg/dL, rising to 4.2-18.8 mg/dL, Alk P ~2 times rising to 5-8 times ULN], resolving in all within 2-6 weeks of stopping). 13221416
Movitt E, Meyer M, Snell A, Goldman M, Gibson J, Sullivan B, Webster J, et al. Jaundice associated with the administration of chlorpromazine, SKF-2601-A (thorazine); report of three cases, with biopsies of the liver. Gastroenterology 1955; 28: 901-13. (3 patients, 1 woman and 2 men, ages 42-73 years with onset of jaundice 1-3 weeks after starting chlorpromazine [bilirubin 5.7-20.8 mg/dL, Alk P 3-10 times ULN], resolving within 4-8 weeks of stopping). 14380602
Werther JL, Korelitz BI. Chlorpromazine jaundice: analysis of twenty-two cases. Am J Med 1957; 22: 351-66. (22 cases of chlorpromazine liver injury seen at one institution and review of literature; onset averaging 15 days after starting, with 1-11 day prodrome of nausea, abdominal pain, and fever followed by jaundice, one with rash; pruritus occasionally present before jaundice; 3 cases were anicteric, highest bilirubin 14.2 mg/dL, Alk P elevated in all except one, duration of jaundice 1 week to 5 months, all ultimately recovered: Case 1). 13402787
Deutsch L, Dickes R, Schenker V. Serial liver function and blood studies in patients receiving chlorpromazine. N Engl J Med 1957; 256: 1-7. (50 patients on chlorpromazine were followed prospectively for liver test abnormalities, elevations in Alk P, bilirubin or BSP retention occurred in 21 [42%], but often returned to normal despite continuing drug; therapy stopped in 8 patients, but none developed significant jaundice). 13388017
Hollister L. Allergy to chlorpromazine manifested by jaundice. Am J Med 1957; 23: 870-9. (Among 900 patients treated with chlorpromazine, 17 [2%] developed jaundice, ages 24-75 years, onset after 1-4 weeks in all except one, fever in 76%, eosinophilia in ~50%, average bilirubin 4.8 mg/dL [highest=14.2 mg/dL], Alk P usually 2-6 fold elevated, jaundice lasting more than a month in 24%, rechallenge in 11 patients led to jaundice in 6 within a few days, but not in 7 patients given promazine). 13487604
Graham GS. Chlorpromazine jaundice in a general hospital. BMJ 1957; 2:1080-1. (Among 65 patients with jaundice seen in 1956, 7 were due to chlorpromazine; onset after 11-28 days, [bilirubin 2.1 to 25 mg/dL, Alk P elevated in all], resolving with stopping in all; resembled obstructive jaundice clinically). 13472055
Zelman S. Liver cell necrosis in chlorpromazine jaundice (allergic cholangitis): a serial study of 26 needle biopsy specimens in nine patients. Am J Med 1959; 27: 708-29. (9 patients seen at a single psychiatric hospital underwent 1 to 5 liver biopsies for chlorpromazine hepatotoxicity; onset 6-30 days after starting, bilirubin peak of 1.9-25.3 mg/dL, ALT 37-318 U/L, Alk P 1-8 times ULN, eosinophilia in 7 patients). 13847249
Melrose AG, Roy JR. Late prognosis of chlorpromazine jaundice. BMJ 1959; 1: 818-9. (52 year old woman and 48 year old man developed jaundice 23 and 19 days after starting chlorpromazine; both had prolonged Alk P elevations and liver biopsy showing chronic injury and fibrosis). 13629130
Mackay EV. Progressive chlorpromazine jaundice during pregnancy. Med J Aust 1960; 47: 209-12. (38 year old woman given chlorpromazine for hyperemesis gravidarum developed jaundice 2 weeks later which persisted for 2 years with pruritus, xanthomata and Alk P elevations that never completely normalized; probable vanishing bile duct syndrome). 14419476
Stewart WR. Chlorpromazine jaundice. Am J Surg 1960; 100: 495-7. (78 year old man developed jaundice 3 weeks after starting chlorpromazine [bilirubin 14.2 mg/dL, Alk P elevated, eosinophils 22%], resolving with stopping). 13834633
Urbinati G, Figliuzzi M. [Jaundice caused by chlorpromazine.] Clin Ter 1960; 18: 611-39. Italian. 13779292
Gaulhofer WK, van der Helm H. [Jaundice caused by chlorpromazine.] Ned Tijdschr Geneeskd 1961; 105: 477-81. Dutch. 13703970
Read AE, Harrison CV, Sherlock S. Chronic chlorpromazine jaundice: with particular reference to its relationship to primary biliary cirrhosis. Am J Med 1961; 31: 249-58. (4 women developed prolonged jaundice due to chlorpromazine, ages 28-57 years, onset in 2-4 weeks, jaundice lasting for 7-36 months, peak bilirubin 15-21.6 mg/dL, Alk P 5-20 times ULN, high cholesterol, xanthomas and weight loss in 3, itching in all; all women, 2 pregnant; ultimately slow recovery, but residual biochemical and histologic abnormalities and fibrosis frequent; probable vanishing bile duct syndrome). 13740051
Gupta NN, Pant SS, Mehrotra RM. Toxic effects of chlorpromazine with special reference to jaundice. Indian J Med Sci 1962; 16: 315-23. (Retrospective evaluation of 75 patients treated with chlorpromazine for 2 to 86 weeks, 18 [24%] had an asymptomatic elevation of Alk P and 1 became jaundiced and pruritus 4 weeks after starting drug [bilirubin 5 mg/dL, Alk P ~3 fold elevated], resolving within 7 weeks of stopping). 13902998
Ruettner JR, Rondez R, Maier C. [Chlorpromazine icterus, a form of cholestatic hepatosis. Clinical-pathological report on 14 observations.]. Dtsch Med Wochenschr 1962; 87: 1107-10. German. 14495139
Waitzkin L. Prolonged hepatic dysfunction after clinical recovery from chlorpromazine jaundice. Gastroenterology 1962; 43: 337-9. (61 year old man developed jaundice 9 days after starting chlorpromazine [peak bilirubin 4 mg/dL], resolving rapidly but with persistent abnormalities of ALT and Alk P for several years without symptoms). 14004438
McQueen EG. Toxic effects of phenothiazine tranquillizers. N Z Med J 1963; 62: 460-2. (Review of the phenothiazines and their side effects; "Jaundice has occurred in about 1% of patients taking chlorpromazine, and also, although less frequently, in patients taking one of the more recently developed analogues"). 14073060
Ranek L. [A fatal case of prolonged chlorpromazine jaundice.]. Ugeskr Laeger 1964; 126: 1271-4. Danish. 14231833
Cook GC, Sherlock S. Jaundice and its relation to therapeutic agents. Lancet 1965; 1: 175-9. (Summary of cases of drug induced liver disease seen at Royal Free Hospital between 1959 and 1965; 11 cases of acute liver failure included 3 due to iproniazid, 2 phenelzine, 2 phenoxypropazine, 1 prochlorperazine, and 3 halogenated anesthetics; 20 cases of cholestatic hepatitis included 18 due to chlorpromazine, 1 perphenazine and 1 nitrofurantoin). 14238042
Dereux J, Dereux JF, Carbonnelle B, Guffroy M, Cacheux S. [Jaundice due to chlorpromazine]. J Sci Med Lille 1965; 83: 565-72. French. 5844831
Albot G, Lunel J, Pagniez V. [Physiopathology of icterus caused by chlorpromazine]. Actual Hepatogastroenterol (Paris) 1966; 2: 467-87. French. 5963841
Levine RA, Briggs GW, Lowell DM. Chronic chlorpromazine cholangiolitic hepatitis. Report of a case with immunofluorescent studies. Gastroenterology 1966; 50: 665-70. (20 year old man developed jaundice 5 days after 8 day course of chlorpromazine with prolonged jaundice, bilirubin rising to 24 mg/dL, with persistent pruritus and xanthomata lasting several years). 5327471
Lunel J, Albot G, Pagniez R. [Critical study of icterus caused by chlorpromazine]. Sem Hop 1966; 42: 1791-807. French. 4287605
Walker CO, Combes B. Biliary cirrhosis induced by chlorpromazine. Gastroenterology 1966; 51: 631-40. (2 patients, 32 year old woman and 31 year old man, developed persistent jaundice [>4 years], cholestasis and liver fibrosis 3 and 4 weeks after starting chlorpromazine; acute cholestatic hepatitis evolving into chronic form with biopsies showing cirrhosis and complications of portal hypertension). 5926937
Bolton BH. Prolonged chlorpromazine jaundice. Am J Gastroenterol 1967; 48: 497-503. (34 year old man developed nausea and malaise followed by jaundice 4 weeks after starting chlorpromazine [bilirubin 7.8 rising to 25 mg/dL, ALT 530 U/L, Alk P ~5 x ULN]; prednisone had no apparent effect and jaundice lasted 19 months, followed by persistence of enzyme elevations and liver biopsy showing fibrosis, no mention of bile duct abnormalities). 5583132
Cheongvee EM, Hurst L, Smith RH. Agranulocytosis and jaundice associated with chlorpromazine. Br J Clin Pract 1967; 21: 95-6. 6037940
L'hirondel J, Venezia R, Rousselot P, Daridon F, Fellouse JC. [Neonatal jaundice due to chlorpromazine]. Arch Fr Pediatr 1968; 25: 1171-7. French. 5713081
de Walden JK. [Influence of chlorpromazine on the hepatic functions]. Acta Biol Med (Gdansk) 1969; 14: 335-69. Polish. 5402667
Eastwood HD. Causes of jaundice in the elderly. A survey of diagnosis and investigation. Gerontol Clin (Basel) 1971; 13: 69-81. 5547261
Poggi E, Ferrari G. [Liver damage due to chlorpromazine and its treatment with arginine glucose-1-phosphate]. Epatologia 1971; 17: 127-31. Italian. 5147857
Ishak KG, Irey NS. Hepatic injury associated with the phenothiazines. Clinicopathologic and follow-up study of 36 patients. Arch Pathol 1972; 93: 283-304. (Review of 36 liver biopsies on phenothiazine induced liver injury from Armed Forces Institute of Pathology files, 33 due to chlorpromazine, 3 prochlorperazine; mean onset 15 days, eosinophilia in 73%, mean bilirubin 12.4 mg/dL, Alk P ~8 fold elevated, ALT 146 U/L; 6 [17%] had prolonged course for 10-16 months). 5017281
Russell RI, Allan JG, Patrick R. Active chronic hepatitis after chlorpromazine ingestion. Br Med J 1973; 1: 655-6. (59 year old man developed jaundice 3 weeks after starting chlorpromazine [bilirubin 9.0 mg/dL, ALT 30 U/L, Alk P 13 times ULN]; subsequent persistence of jaundice with biopsy showing fibrosis, ALT levels remaining normal, Alk P high and increased globulins but ANA negative; thus, chronic cholestasis rather than chronic active hepatitis). 4692711
Morera Prat J, Vidal Pla R, Mari ML. [Primary biliary cirrhosis after a prolonged ingestion of chlorpromazine]. Rev Clin Esp 1976; 142: 483-5. Spanish. 968137
Nerad V, Skaunic V. [Chronic intrahepatic cholestasis following chlorpromazine; treated using phenobarbital]. Sb Ved Pr Lek Fak Karlovy Univerzity Hradci Kralove Suppl 1976; 19: 721-7. Czech. 1088626
Glazier RL, Crowell EB Jr. Factor VIII inhibition associated with chlorpromazine-induced hepatic injury. Thromb Haemost 1977; 37: 523-6. 578031
Nartowicz A, Mirska K, Slowik J. [Jaundice following administration of chlorpromazine to a 21/2-month-old infant]. Pediatr Pol 1977; 52: 217-8. Polish. 840523
Boyer JL. Mechanisms of chlorpromazine cholestasis: hypersensitivity or toxic metabolite? Gastroenterology 1978; 74: 1331-3. (Chlorpromazine may have direct effects on hepatocytes and cholestasis may relate to production of free radicals, metabolic intermediates and effects on liver membranes). 648827
Weinreb M, Kraus V, Krausová, Hudcová. Negligible hepatotoxicity of chlorpromazine in long-term therapy. Act Nerv Super (Praha) 1978; 20: 280-1. 735735
Johnson EI, Lanford RE, Solomon K. Chlorpromazine, eosinophilia, and hepatotoxicity. Va Med 1979; 106: 683-4. 484004
Zhang ZY. [Observations of liver function in patients with long term administration of chlorpromazine (author's transl)]. Zhonghua Shen Jing Jing Shen Ke Za Zhi 1979; 12: 107-8. Chinese. 263043
Das UN. Chlorpromazine induced cholestasis and prostaglandins. J Indian Med Assoc 1980; 74: 121. 7410873
Paumgartner G, Paumgartner D. [Damage to liver and biliary tracts by long-term drug therapy (author's transl)]. MMW Munch Med Wochenschr 1980; 122: 1223-6. German. 6777679
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, 51 [9%, ranking 2nd behind halothane] were attributed to chlorpromazine, latency averaging 14 days [range 11-46]; 5 deaths). 6982502
Kaplowitz N, Aw TY, Simon FR, Stolz A. Drug-induced hepatotoxicity. Ann Intern Med 1986; 104: 826-39. (Review of drug induced hepatotoxicity including chlorpromazine jaundice). 3518564
Munyon WH, Salo R, Briones DF. Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl) 1987; 91: 182-8. (In vitro assay for cytotoxicity of 8 neuroleptic drugs showed that chlorpromazine was more toxic than haloperidol and loxapine, but similar to other phenothiazines). 2883697
Regal RE, Bili JE, Glazer HM. Phenothiazine-induced cholestatic jaundice. Clin Pharm 1987; 6: 787-94. (Review of phenothiazine induced liver injury; cross sensitivity is rare "but does exist"). 2905941
Lok AS, Ng IO. Prochlorperazine-induced chronic cholestasis. J Hepatol 1988; 6: 369-73. (68 year old man developed jaundice 4 weeks after starting prochlorperazine [peak bilirubin 26 mg/dL, ALT 50-90 U/L, Alk P 120-500 U/L], jaundice and pruritus persisting for more than a year, but then gradual clinical improvement but with persistent enzyme elevations, and biopsy 22 months after onset showed fibrosis and paucity of bile ducts). 3392386
Bach N, Thung SN, Schaffner F, Tobias H. Exaggerated cholestasis and hepatic fibrosis following simultaneous administration of chlorpromazine and sodium valproate. Dig Dis Sci 1989; 34: 1303-7. (45 year old man developed fatigue and fever 12 days after starting chlorpromazine for intractable hiccups [bilirubin 21.5 mg/dL, ALT 1312 U/L, Alk P 617 U/L], with persistent jaundice and pruritus for several years and eventual presence of cirrhosis and varices; paucity of bile ducts on biopsy). 2502367
Sidi Y, Douer D, Pinkhas J. Simultaneous appearance of agranulocytosis and cholestatic jaundice following chlorpromazine treatment. Med Interne 1989; 27: 69-71. 2749161
Ben-Yehuda A, Bloom A, Lijovetzky G, Flusser D, Tur-Kaspa R. Chlorpromazine-induced liver and bone marrow granulomas associated with agranulocytosis. Isr J Med Sci 1990; 26: 449-51. (35 year old woman developed neutropenia 2 months after starting chlorpromazine with oral ulcers, fever and agranulocytosis with recovery within a few weeks; high Alk P [normal ALT and bilirubin] led to liver and bone marrow biopsy which showed granulomas). 2401609
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Among 1100 cases of drug induced liver injury reported between 1978 and 1987 in Denmark, 24 were due to chlorpromazine with 1 fatality). 1506809
Derby LE, Gutthann SP, Jick H, Dean AD. Liver disorders in patients receiving chlorpromazine or isoniazid. Pharmacotherapy 1993; 13: 353-8. (Analysis of databases of clinical information from clinicians in the UK; among 10,502 persons given chlorpromazine, 14 developed possible liver injury, for a population based rate of 1.3/1000 users; risk factors were first prescription and age [12-fold increased risk for >70 vs <50 years], but not sex). 8361861
Moradpour D, Altorfer J, Flury R, Greminger P, Meyenberger C, Jost R, Schmid M. Chlorpromazine-induced vanishing bile duct syndrome leading to biliary cirrhosis. Hepatology 1994; 20: 1437-41. (33 year old pregnant woman had onset of jaundice 2 weeks after starting chlorpromazine, jaundice lasting 22 months with pruritus and high Alk P; ultimately resolving jaundice, but with biliary cirrhosis and absence of bile ducts: Case 2). 7982642
Wang CK, Liu JD, Lin SY, Liao LY, Cheng NY, Wang CS, Siauw CP, et al. Drug-induced liver disease--a review of 14 cases. Gaoxiong Yi Xue Ke Xue Za Zhi 1995; 11: 213-9. (Among 14 cases of drug induced liver disease seen between 1986-1991 at one hospital in Taiwan, 2 were due to isoniazid/rifampin, 2 oral contraceptives, 1 each for aspirin, chlorpromazine, mefenamic acid, acetaminophen, ketoconazole, paraquat, trimethoprim-sulfamethoxazole, chenodeoxycholate, "cold" pill and herbals). 7602656
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Between 1974 and 1995, New Zealand registry received 943 reports of liver injury involving 205 drugs; chlorpromazine was listed in the top 20 drugs implicated, but proportions fell over the 21 year period from 4.2% to 2.9% to 1.5% of cases, one fatality). 8816722
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry 1999; 156: 1686-96. (Systematic review of 81 articles on weight change with antipsychotics; using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg). 10553730
Chlumská, CuríR, Boudová, Mukensnabl P, Klvana P. Chlorpromazine-induced cholestatic liver disease with ductopenia. Cesk Patol 2001; 37: 118-22. 11669021
Andrade RJ, Lucena MI, Fernáez MC, Pelaez G, Pachkoria K, GarcíRuiz E, GarcíMuñB, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. 2005; 129: 512-21. (461 cases of drug induced liver injury reported in Spain between 1994 and 2004, no phenothiazines were mentioned among the most common causes [those with more than 5 cases]). 16083708
De Valle MB, Av Klinteberg V, Alem N, Olsson R, Bjöson E. Drug-induced liver injury in a Swedish University hospital out-patient hepatology clinic. Aliment Pharmacol Ther 2006; 24: 1187-95. (Among 77 cases of drug induced liver injury seen between 1995 and 2005 at a single Swedish hospital, none were due to phenothiazines). 17014577
Minondo Amuchasteguia L, Egiguren Urrosolo L, Zapata Morcillo E, Castiella Eguzkiza A. [Chlorpromazine-induced cholestatic hepatitis in intractable hiccups]. Gastroenterol Hepatol 2007; 30: 103. Spanish. (78 year old man developed weakness and dark urine during 12 day course of chlorpromazine for hiccups [bilirubin 2.8 mg/dL, ALT 222 U/L, Alk P 291 U/L] without fever or eosinophilia; resolving within 2 months of stopping). 17335721
Sabaté, Ibánez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993 and 2000, 3 were due to chlorpromazine with relative risk of 613: frequency of 261 per 100,000 person year exposures). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to phenothiazines). 18955056
Flanagan RJ. Fatal toxicity of drugs used in psychiatry. Hum Psychopharmacol 2008; 23 Suppl 1: 43-51. (Deaths from fatal poisonings decreased in England and Wales between 1993-2004, antipsychotic overdose fatalities higher for phenothiazines than atypicals; deaths/million prescriptions being 29 for chlorpromazine, 15.5 thioridazine, 3.9 trifluoperazine, 13.3 olanzapine, 21 clozapine and 31.3 quetiapine; deaths were due to respiratory depression and not acute liver failure). 18098225
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for phenothiazines). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine). 21788760
Marwick KF, Taylor M, Walker SW. Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol 2012; 35: 244-53. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5% to 78% and "clinically significant' elevations in 0% to 15%, highest rates being reported with haloperidol, olanzapine, risperidone, clozapine, perphenazine and perazine; chlorpromazine is reported to cause severe injury and several fatal cases have been published). 22986798
Jaiprakash H, Narayana S, Mohanraj J. Drug-induced hepatotoxicity in a tertiary care hospital in rural South India. N Am J Med Sci 2012; 4: 90-3. (During a one year period, 65 cases of drug induced liver injury were seen in a rural hospital in South India, the most common causes being antituberculosis medications and cholesterol lowering drugs; chlorpromazine accounted for ~2 cases). 22408755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period including one non-fatal but icteric case due to chlorpromazine). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, one non-fatal, but icteric case [from 2003] was attributed to chlorpromazine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.4%] were attributed to antipsychotic agents, including 3 to quetiapine and 2 olanzapine, but none chlorpromazine. 25754159

## OTHER REFERENCE LINKS

1. Recent References on Chlorpromazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chlorpromazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Chlorpromazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chlorpromazine)